# Propafenone

## OVERVIEW

### Introduction

Propafenone is an oral antiarrhythmic agent that has been in wide use for several decades. Long term propafenone therapy is associated with a low rate of serum aminotransferase elevations and therapy rarely can cause a self-limited, acute cholestatic liver injury.

### Background

Propafenone (proe" pa fee' none) is an analogue of the local anesthetic procaine and has electrophysiological effects that resemble quinidine (antiarrhythmic Class IC). Propafenone appears to act by blocking open sodium channels and outward potassium channels. As a consequence, it decreases cardiac automaticity, increases refractory periods and slows conduction. Propafenone was approved for use in the United States in 1989, and current approved indications include prevention of recurrence of symptomatic atrial fibrillation after cardioversion in patients without structural heart disease, and for suppression of life threatening ventricular arrhythmias. Propafenone is available as tablets of 150, 225 and 300 mg and as extended release capsules of 225, 325 and 425 mg generically and under the brand name Rythmol. The usual maintenance dose in adults of standard release forms is 150 to 300 mg every 8 hours and 225 to 425 mg of the sustained release forms every 12 hours. The most common side effects include dizziness, palpitations, chest pain, dyspnea, fatigue, headache, anxiety, gastrointestinal upset, change in taste and blurred vision.

### Hepatotoxicity

In clinical trials, propafenone was associated with a low rate of serum aminotransferase and alkaline phosphatase elevations. Since its approval and more widescale use, propafenone has been linked to rare instances of clinically apparent liver injury, at least a dozen cases of which have been reported in the literature. Patients usually present with symptoms of jaundice and pruritus 2 to 8 weeks after starting propafenone, and the pattern of serum enzyme elevations are typically mixed (Case 1) or cholestatic (Case 2). Immunoallergic and autoimmune features are uncommon. While the jaundice can be prolonged, patients typically recover in 1 to 3 months and there have been no instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome attributed to its use.

Likelihood score: B (rare but likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which propafenone causes liver injury is unknown. Propafenone is extensively metabolized in the liver by the cytochrome P450 system, predominantly CYP 2D6 and is sensitive to drug-drug interactions and hypermetabolizer status.

### Outcome and Management

The severity of hepatic injury due to propafenone ranges from mild and transient serum enzyme elevations to acute cholestatic hepatitis. Propafenone has not been linked to acute liver failure, chronic liver injury or vanishing bile duct syndrome. Recurrence upon reexposure is common and should be avoided. There is no evidence for cross sensitivity to the hepatic injury of propafenone with other antiarrhythmic agents.

Drug Class: Antiarrhythmic Agents

## CASE REPORTS

### Case 1. Cholestatic hepatitis due to propafenone.(1)

A 73 year old woman developed itching two weeks after starting propafenone (450 mg daily) for atrial fibrillation. She denied jaundice, abdominal pain, rash and fever. She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. She had known atherosclerosis, coronary artery disease, cerebrovascular disease, transient ischemic attacks, chronic obstructive pulmonary disease, diabetes and dyslipidemia. Her medications taken chronically included aspirin (100 mg daily), isosorbide mononitrate (20 mg twice daily), NPH insulin (8 units daily), glibenclamide (5 mg three times daily) and metformin (850 mg daily). Laboratory testing showed elevations in serum enzymes, but normal bilirubin (Table). Tests for hepatitis A, B and C were negative and ultrasound of the liver showed no evidence for biliary obstruction. Once propafenone was stopped and replaced by verapamil (120 mg daily), serum enzymes fell into the normal range. When she redeveloped atrial fibrillation 6 months later, propafenone was restarted, but her serum enzymes rapidly became abnormal, and it was again stopped. Five weeks later she redeveloped itching and was again found to have elevations in serum enzymes. On questioning, she reported restarting propafenone on her own.

#### Key Points

Medication: | Propafenone (450 mg daily)
Pattern: | Mixed (R=2.1)
Severity: | 1+ (enzyme elevations without jaundice)
Latency: | 2 weeks
Recovery: | 4 weeks
Other medications: | Aspirin, glibenclamide, metformin, isosorbide mononitrate, insulin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 10 | 58
0 | | 15 | 53
2 weeks | 0 | 125 | 148 | 0.5 | Itching
4 weeks | 0 | 100 | 268 | 0.6 | Propafenone stopped
7 weeks | 3 weeks | 34 | 148
9 weeks | 5 days | 14 | 72
Propafenone restarted due to recurrence of atrial fibrillation
0 | | 18 | 65
2 weeks | 0 | 145 | 240 | | Propafenone stopped
4 weeks | 2 weeks | 24 | 125
7 weeks | 5 weeks | 14 | 45
Propafenone restarted by the patient
1 weeks | 0 | 150 | 275 | | Itching, drug stopped
3 weeks | 2 weeks | 16 | 70
Normal Values | | <42 | <115 | <1.2

#### Comment

This patient developed a mixed pattern of serum enzyme elevations without jaundice on three occasions while taking propafenone. On each occasion, she was symptomatic with itching, suggesting a cholestatic liver injury. At least a dozen cases of cholestatic hepatitis have been reported associated with propafenone use. The latency to onset has ranged from 1 to 6 weeks and the pattern of enzyme elevation is usually cholestatic or mixed. Most patients have had mild jaundice and all cases have recovered with stopping the medication. As this case demonstrates, recurrence on reexposure is typical, the recurrences having a similar latency and severity. This phenomenon is different from cases of drug induced immunoallergic hepatitis that usually recur within days of reexposure with a more severe and abrupt onset and course.

[Translation courtesy of Dr. Yaron Rotman.]

### Case 2. Cholestatic hepatitis due to propafenone.(2)

A 62 year old woman was found to have abnormal liver tests one month after starting propafenone (450 mg daily) for atrial fibrillation. At that point, she had no symptoms of liver disease and specifically denied abdominal pain, dark urine, rash and fever. She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. She had a history of breast cancer treated with mastectomy 30 years previously. She also had adult-onset diabetes for which she took insulin. The liver test abnormalities were thought to be due to malignancy and because the arrhythmias were not adequately controlled, propafenone was continued and the dose was increased to 600 mg daily. Over the next few weeks she developed nausea and liver tests worsened (Table). Tests for hepatitis A, B and C were negative as were autoantibodies. Ultrasound and computerized tomography of the abdomen showed no evidence of biliary obstruction, gall stones or malignancy. Propafenone was discontinued and she was treated with sotalol (150 mg daily). Over the next two months, liver tests returned to normal.

#### Key Points

Medication: | Propafenone (450 to 600 mg daily)
Pattern: | Cholestatic (R=1.2)
Severity: | 1+ (enzyme elevations and symptoms without jaundice)
Latency: | 4 weeks
Recovery: | 7 weeks
Other medications: | Insulin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 18 | 182 | 0.6 | Atrial fibrillation
0 | | 12 | 185 | 0.7 | Propafenone started
4 weeks | 0 | 202 | 1489 | 1.2 | Dose increase
5 weeks | 0 | 160 | 2156 | 1.3 | Nausea
Propafenone stopped
8 weeks | 4 weeks | 41 | 992 | 0.5
12 weeks | 7 weeks | 25 | 235 | 0.5
Normal Values | | <31 | <240 | <1.2

#### Comment

This patient developed a mild cholestatic hepatitis within a month of starting propafenone. The abnormal liver tests were initially attributed to possible malignancy, but after lack of evidence of cancer on imaging, propafenone was considered the likely cause and it was discontinued, whereupon symptoms rapidly improved and liver tests returned to normal within the next two months. Typical of propafenone is the latency to onset of 3-6 weeks, mild cholestatic hepatitis and prompt improvement on stopping.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Propafenone – Generic, Rythmol®

DRUG CLASS

Antiarrhythmic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Propafenone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Propafenone | 54063-53-5 | C21-H27-N-O3

## CITED REFERENCES

1 Arinzon Z, Fridman R. (2001). Harefuah.
2 La Brocca A. (2002). Ann Ital Med Int.

## ANNOTATED BIBLIOGRAPHY

References updated: 07 September 2021

Zimmerman HJ. Antiarrhythmics. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 642-4. (Expert review of hepatotoxicity of antiarrhythmics published in 1999; mentions that propafenone is a rare cause of cholestatic jaundice).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 524. (Review of hepatotoxicity of cardiovascular agents mentions that propafenone can cause a mixed pattern of injury usually after 2-6 weeks of therapy).
Knollmann BC, Roden DM. Antiarrhythmic drugs. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 547-72. (Textbook of pharmacology and therapeutics).
Schuff-Werner P, Kaiser D. (1980). Dtsch Med Wochenschr. (Two cases; 35 year old woman developed malaise 4 weeks after starting propafenone [bilirubin 1.1 mg/dL, ALT 289 U/L, Alk P 826 U/L], resolving within 4 weeks of stopping; 60 year old woman developed malaise within days of starting propafenone [ALT 115 U/L, Alk P slightly elevated], resolving within 2 weeks).
Schuff-Werner P, Kaiser D, Lüders CJ, Berg PA. (1981). Z Gastroenterol. (Further analysis of previously reported cases, one had positive lymphocyte stimulation to propafenone).
Konz KH, Berg PA, Seipel L. (1984). Dtsch Med Wochenschr. (84 year old man developed nausea 6 days after starting propafenone followed by jaundice and pruritus [bilirubin 10.8 mg/dL, ALT 57 U/L, Alk P 515 U/L], with recovery in two months; patient then gave history of jaundice during previous course of propafenone arising after 33 days with cholestatic course).
Libersa C, Caron J, Pladys A, Beuscart R, Kacet S, Wajman A, Connell C, et al. (1987). Propafenone versus disopyramide: a double-blind randomized crossover trial in patients presenting chronic ventricular arrhythmias. Clin Cardiol. (Ten patients with ventricular arrhythmias were treated with disopyramide vs propafenone vs placebo in a crossover study for 6 days each; no change in chemical parameters).
Jonason T, Ringqvist I, Bandh S, Nilsson G, Nilsson H, Lidell C, Bjerle P, et al. (1988). Propafenone versus disopyramide for treatment of chronic symptomatic ventricular arrhythmias. A multicenter study. Acta Med Scand. (38 patients with symptomatic ventricular arrhythmias were treated with either propafenone or disopyramide for 28 days; propafenone had fewer side effects; no mention of liver injury or ALT elevations).
Funck-Brentano C, Kroemer HK, Lee JT, Roden DM. (1990). Propafenone. N Engl J Med. (Review of propafenone; approved for severe ventricular arrhythmias; common side effects are dizziness, taste disturbances, blurred vision and nausea. Rare cases of cholestatic hepatitis have been reported).
(1990). Propafenone for cardiac arrhythmias. Med Lett Drugs Ther. (Short summary of efficacy and safety of propafenone published soon after its approval in the US; adverse effects include dizziness, change in taste, blurred vision, abdominal discomfort, anorexia, and nausea; can worsen heart failure; no mention of hepatic adverse effects).
Spinler SA, Elder CA, Kindwall KE. (1992). Propafenone-induced liver injury. Ann Pharmacother. (71 year old woman developed serum enzyme elevations without symptoms 1 month after starting propafenone [bilirubin 1.1 mg/dL, ALT 80 U/L, Alk P 512 U/L], not resolving on lowering dose, but resolving within 2 months of stopping).
Mondardini A, Pasquino P, Bernardi P, Aluffi E, Tartaglino B, Mazzucco G, Bonino F, et al. (1993). Propafenone-induced liver injury: report of a case and review of the literature. Gastroenterology. (66 year old man took propafenone for 2 weeks, presenting ten days later with jaundice and pruritus [bilirubin 6.2 mg/dL, ALT 127 U/L, Alk P 553 U/L], resolving on stopping and reappearing within 2 weeks of restarting).
Elizalde JI, Batallier R, Bruix J, Rodes J. (1994). Gastroenterol Hepatol. (62 year old man developed fatigue at 3 and jaundice at 6 weeks after starting propafenone [bilirubin 6.8 mg/dL, ALT 501 U/L, Alk P 1512 U/L], resolving 2 months after stopping).
Crijns HJ, Gosselink AT, Lie KI. (1996). Propafenone versus disopyramide for maintenance of sinus rhythm after electrical cardioversion of chronic atrial fibrillation: a randomized, double-blind study. PRODIS Study Group. Cardiovasc Drugs Ther. (Controlled trial of propafenone vs disopyramide in 56 patients after cardioversion of atrial fibrillation; similar efficacy, but side effects were more frequent with disopyramide; no mention of hepatic side effects or ALT elevations).
Aliot E, Denjoy I. (1996). Comparison of the safety and efficacy of flecainide versus propafenone in hospital out-patients with symptomatic paroxysmal atrial fibrillation/ flutter. The Flecainide AF French Study Group. Am J Cardiol. (In a controlled trial in 96 patients with episodic atrial fibrillation, oral flecainide and propafenone were equally effective, but side effects were common, largely dizziness, headache and gastrointestinal disturbances; no mention of ALT elevations or hepatotoxicity).
Chimienti M, Cullen MT, Casadei G. (1996). Safety of long-term flecainide and propafenone in the management of patients with symptomatic paroxysmal atrial fibrillation: report from the Flecainide and Propafenone Italian Study Investigators. Am J Cardiol. (In a controlled trial in 200 patients with episodic atrial fibrillation, oral flecainide and propafenone had similar efficacy and tolerance; no mention of ALT elevations or hepatotoxicity).
Roden DM. (2000). Antiarrhythmic drugs: from mechanisms to clinical practice. Heart. (Overview of antiarrhythmic drugs which are separated in four classes based upon molecular target: I being sodium channel blockers; II beta blockers; III potassium channel blockers; and, IV calcium channel blockers; some agents having multiple targets).
Arinzon Z, Fridman R. (2001). Harefuah. (73 year old woman developed itching 2 weeks after starting propafenone [bilirubin 0.5 mg/dL, ALT 125 U/L, Alk P 148 U/L], values becoming normal after it was stopped and both symptoms and liver enzyme abnormalities returning on restarting two more times [bilirubin always normal and peak Alk P 268 U/L: Case 1).
Gandolfi A, Rota E, Zanghieri G, Tolomelli S, Bagnulo A, Mengoli M. (2001). Recenti Prog Med. (Case of self-limited acute cholestatic hepatitis arising 3 weeks after starting propafenone: abstract only).
La Brocca A. (2002). Ann Ital Med Int. (62 year old woman developed nausea and abnormal liver tests two months after starting propafenone for atrial fibrillation [bilirubin 1.4 mg/dL, ALT 202 U/L, Alk P 1489 U/L], resolving within two months of stopping: Case 2).
Grieco A, Forgione A, Giorgi A, Miele L, Gasbarrini G. (2002). Propafenone-related cholestatic hepatitis in an elderly patient. Ital Heart J. (84 year old man developed pruritus and jaundice 3 weeks after starting propafenone [bilirubin 10.7 mg/dL, ALT 116 U/L, Alk P 1655 U/L], resolving over next 8 weeks).
McNamara RL, Tamariz LJ, Segal JB, Bass EB. (2003). Management of atrial fibrillation: review of the evidence for the role of pharmacologic therapy, electrical cardioversion, and echocardiography. Ann Intern Med. (Systematic review of literature on efficacy and safety of drugs for atrial fibrillation; propafenone has been shown to be effective in conversion of atrial fibrillation to normal sinus rhythm and its subsequent maintenance; hepatic side effects are not discussed).
Cocozzella D, Curciarello J, Corallini O, Olivera A, Alburquerque MM, Fraquelli E, Zamagna L, et al. (2003). Propafenone hepatotoxicity: report of two new cases. Dig Dis Sci. (2 cases; 67 year old woman developed jaundice and pruritus 6 weeks after starting propafenone [bilirubin 3.6 mg/dL, ALT 22 U/L, Alk P 770 U/L], resolving in 2 weeks; 69 year old woman developed jaundice and pruritus 7 months after starting propafenone [bilirubin 7.4 mg/dL, ALT 100 U/L, Alk P 1020 U/L], resolving in several months).
Marrtín EP, Cervantes JL, Yangüela J. (2004). Rev Esp Enferm Dig. (76 year old woman developed fatigue 1 month after starting propafenone [bilirubin 1.6 mg/dL, ALT 208 U/L, Alk P 1257 U/L], resolving almost completely within 3 weeks of stopping).
(2007). Drugs for cardiac arrhythmias. Treat Guidel Med Lett. (Concise review of drugs for arrhythmias; propafenone is effective in preventing paroxysmal supraventricular tachycardia and atrial fibrillation in “otherwise healthy hearts”; mentions hepatotoxicity as an adverse event).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J. (2008). Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 2 cases were attributed to amiodarone and 1 to profafenone, but none to other antiarrhythmic agents).
(2010). Treatment of atrial fibrillation. Treat Guidel Med Lett. (Concise review of efficacy and safety of drugs for atrial fibrillation; propafenone is effective in maintaining sinus rhythm after cardioversion and is generally reserved for patients with structurally normal hearts; side effects can include bradycardia, dizziness, blurred vision, nervousness and headache; no mention of hepatotoxicity or ALT elevations).
Camm J. (2012). Antiarrhythmic drugs for the maintenance of sinus rhythm: risks and benefits. Int J Cardiol. (Review of the safety and efficacy of antiarrhythmic drugs used to maintain normal sinus rhythm; no discussion of hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to propafenone).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to propafenone).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al. (2015). United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 were attributed to antiarrhythmics including 5 to amiodarone and 2 to dronedarone, but none were linked to propafenone).
Younan LB, Barada KA, Faraj WG, Tawil AN, Jabbour MN, Khoury MY, El-Majzoub NM, et al. (2013). Propafenone hepatotoxicity: report of a new case and review of the literature. Saudi J Gastroenterol. (67 year old woman developed jaundice 4 weeks after starting propafenone [300 mg daily] for atrial fibrillation [bilirubin 9.7 mg/dL, ALT 213 U/L, Alk P 384 U/L], with slow resolution upon stopping).
(2019). Drugs for atrial fibrillation. Med Lett Drugs Ther. (Concise summary of the mechanisms of action, clinical efficacy, safety and costs of drugs used to treat atrial fibrillation mentions that propafenone is a second line agent, whose use should be restricted to patients without structural heart disease and only in combination with a beta blocker; mentions that it has been linked to cases of hepatotoxicity).
D'Angelo RN, Rahman M, Khanna R, Yeh RW, Goldstein L, Yadalam S, Kalsekar I, et al. (2021). Limited duration of antiarrhythmic drug use for newly diagnosed atrial fibrillation in a nationwide population under age 65. J Cardiovasc Electrophysiol. (In a national sample of patients, ages 20 to 64 years, who were started on an antiarrhythmic agent within 90 days of diagnosis of atrial fibrillation, the most frequently used agents were flecainide [27%] , amiodarone [23%], dronedarone [14%], sotalol [16%], and propafenone [14%], and an average of 72% discontinued the therapy within 2 years of starting, most commonly because of ablation therapy).

## OTHER REFERENCE LINKS

1 Recent References on Propafenone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Propafenone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Propafenone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Propafenone)